# Cobimetinib

## OVERVIEW

### Introduction

Cobimetinib is a tyrosine kinase receptor inhibitor that is used in combination with vemurafenib as therapy for selected forms of advanced malignant melanoma. The combination of cobimetinib and vemurafenib is commonly associated with serum enzyme elevations during therapy and to rare instances of clinically apparent acute liver injury.

### Background

Cobimetinib (koe" bi me' ti nib) is a small molecule tyrosine kinase receptor inhibitor with potent activity against the mitogen-activated extracellular regulated kinase (MEK), which is an important component of the kinase cascade in the mitogen activated protein kinase (MAPK) pathway (RAS-RAF-MEK-ERK). Components of the MAPK pathways are frequently mutated in patients with malignant melanoma, particularly the RAF isoform BRAF. BRAF-mutations cause a constitutive activation of the MAPK pathways, resulting in unregulated cell growth and proliferation. Inhibition of MEK has been found to be synergistic when combined with specific BRAF inhibitors as therapy of BRAF-mutated cancers. Clinical trials have shown that the addition of cobimetinib with vemurafenib (a specific BRAF-kinase inhibitor) results in improvements in survival in patients with melanoma who harbor the V600 BRAF mutation. Cobimetinib received accelerated approval for use as combination therapy with vemurafenib in the United States in 2015. Current indications are as combination therapy of metastatic or unresectable melanoma with BRAF V600E or V600K mutations. Cobimetinib is available in tablets of 20 mg under the brand name Cotellic. The recommended dose is 60 mg once daily for the first 21 days of each 28-day cycle, continued until disease progression or intolerable toxicity occurs. Side effects are common and include diarrhea, rash, photosensitivity, nausea, stomatitis, fever, alopecia and thrombocytopenia. Uncommon, but potentially severe side effects include severe diarrhea leading to dehydration and renal failure, rhabdomyolysis, cardiac toxicity, retinal detachment and embryo-fetal toxicity.

### Hepatotoxicity

Elevations in serum aminotransferase and alkaline phosphatase levels are common during vemurafenib therapy and are even more common when it is combined with cobimetinib, abnormal liver tests occurring in 26% to 70% of treated patients and ALT values rising above 5 times the upper limit of the normal range (ULN) in 6% to 12%. Instances of clinically apparent liver injury with jaundice have also been reported during the clinical trials of cobimetinib and vemurafenib therapy, but the clinical features, course and outcomes of these episodes have not been described in detail. At least one instance of hepatocellular injury with jaundice was included in the initial safety review of cobimetinib. The MAPK pathway inhibitors as a class are often associated with transient serum enzyme elevations and more rarely with instances of clinically apparent liver injury, but the clinical features have not been described and the association with cobimetinib not clearly defined. The rate of clinically significant liver injury and hepatic failure associated with protein kinase inhibitors is increased in patients with preexisting cirrhosis or hepatic impairment due to liver tumor burden.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury that occurs during therapy with MAPK pathway inhibitors is not well understood, but may relate to the direct effects of inhibition of these enzymes on hepatocytes. Cobimetinibb is metabolized in the liver via the cytochrome P450 system, predominantly CYP 3A and is susceptible to drug-drug interactions with strong inhibitors or inducers of this microsomal enzyme.

### Outcome and Management

Liver injury due to cobimetinib varies in severity from minor, transient serum enzyme elevations to acute symptomatic hepatitis. The product label for cobimetinib recommends monitoring of routine liver tests during treatment. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to temporary discontinuation, which should be permanent if laboratory values do not improve significantly or resolve within a few weeks. Restarting therapy is usually, but not always followed by recurrence of the serum enzyme elevations. There does not appear to be cross reactivity with other tyrosine kinase receptor inhibitors and, in some situations, switching to another protein kinase inhibitor may be appropriate.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Related Drugs: Trametinib, Vemurafenib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cobimetinib – Cotellic®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Cobimetinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Cobimetinib | 934660-93-2 | C21-H21-F3-I-N3-O2 | Cobimetinib structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 June 2017

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556-7. (Review of hepatotoxicity of cancer chemotherapeutic agents; discusses gefitinib, erlotinib and crizotinib but not cobimetinib).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Larkin J, Ascierto PA, Dréno B, Atkinson V, Liszkay G, Maio M, Mandalà M, et al. Combined vemurafenib and cobimetinib in BRAF-mutated melanoma. N Engl J Med 2014; 371: 1867-76. (Among 495 patients with untreated, unresectable or metastatic BRAF V600 mutation-positive melanoma treated with vemurafenib with vs without cobimetinib, overall and progression free survival was greater with the combination as were adverse events with ALT elevations in 24% vs 19% that were above 5 times ULN in 12% vs 7%). 25265494
Ribas A, Gonzalez R, Pavlick A, Hamid O, Gajewski TF, Daud A, Flaherty L, et al. Combination of vemurafenib and cobimetinib in patients with advanced BRAF (V600)-mutated melanoma: a phase 1b study. Lancet Onco. 2014; 15: 954-65. (Among 129 patients with advanced, BRAF V600 mutated melanoma treated with 10 different combination regimens of vemurafenib and cobimetinib, dose limiting toxicities were fatigue, QTc interval prolongation, stomatitis and myalgia and arthralgia while liver test abnormalities arose in 50% of patients, with ALT elevations in 21%, that were above 5 times ULN in 5%). 25037139
Patel U, Cornelius L, Anadkat MJ. MEK inhibitor-induced dusky erythema: characteristic drug hypersensitivity manifestation in 3 patients. JAMA Dermatol 2015; 151: 78-81. (Three patients with advanced malignancies developed skin rashes and evidence of drug hypersensitivity within 1-7 weeks of starting therapy with 3 different MEK-inhibitors [selumetinib, cobimetinib and trametinib], resolving with stopping and, in two instances, after corticosteroid therapy, not recurring upon restarting the same agent). 25426865
Ascierto PA, McArthur GA, Dréno B, Atkinson V, Liszkay G, Di Giacomo AM, Mandalà M, et al. Cobimetinibb combined with vemurafenib in advanced BRAF (V600)-mutant melanoma (coBRIM): updated efficacy results from a randomised, double-blind, phase 3 trial. Lancet Oncol 2016; 17: 1248-60. (Follow up of study of Larkin et al [2014] in 495 patients with advanced BRAF-V600 mutant melanoma, found median overall survival was greater with the combination of cobimetinib and vemurafenib vs vemurafenib alone [22.3 vs 17.4 months] as were serious adverse events [37% vs 28%], any ALT elevation [26% vs 18%] and ALT elevations above 5 times ULN [11% vs 6%]). 27480103
Cobimetinibb (Cotellic) for metastatic melanoma. Med Lett Drugs Ther 2016; 58 (1491): 43-4. (Concise review of the mechanism of action, pharmacology, clinical efficacy, toxicity and costs of cobimetinib shortly after its approval in the US; mentions that serum enzyme elevations are common during cobimetinib therapy, but does not mention clinically apparent liver injury or hepatic failure). 27027689
Rosen LS, LoRusso P, Ma WW, Goldman JW, Weise A, Colevas AD, Adjei A, et al. A first-in-human phase I study to evaluate the MEK1/2 inhibitor, cobimetinib, administered daily in patients with advanced solid tumors. Invest New Drugs 2016; 34: 604-13. (Among 97 patients with various forms of advanced malignancies treated with different doses and regimens of cobimetinib in a phase 1 study, dose-limiting toxicities included hepatic encephalopathy, diarrhea, rash and blurred vision while common adverse events were diarrhea, rash, fatigue, edema, nausea; clinical responses occurred only in patients with melanoma, most of whom had BRAF V600E mutations). 27424159
Signorelli J, Shah Gandhi A. Cobimetinibb. Ann Pharmacother 2017; 51: 146-53. (Review of the pharmacology, efficacy and safety of cobimetinib in combination with vemurafenib; mentions that the most frequent adverse events are rash [87%], diarrhea [83%], fatigue [70%], photosensitivity [67%], and liver enzyme elevations [67%]; no mention of clinically apparent liver injury or liver related mortality). 27701080

## OTHER REFERENCE LINKS

1. Recent References on Cobimetinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Cobimetinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cobimetinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cobimetinib)